# Anifrolumab

## OVERVIEW

### Introduction

Anifrolumab is a human monoclonal antibody to the type 1 interferon receptor which is used in the therapy of moderate-to-severe systemic lupus erythematous. Anifrolumab has been linked to a low incidence of transient serum enzyme elevations during therapy and has not been linked to instances of clinically apparent liver injury.

### Background

Anifrolumab (an” i frol’ ue mab) is a human monoclonal IgG1 antibody to the type 1 interferon (IFN) receptor subunit 1 which is used to treat adults with moderate-to-severe systemic lupus erythematosus (SLE). Anifrolumab binds to type 1 interferon receptors blocking their activation and induction of interferon related genes. This monoclonal antibody has been shown to be effective in reducing disease activity in patients with systemic lupus erythematosus, a disease marked by elevated levels of soluble interferon gene induced proteins with immune dysregulation and production of pathogenic autoantibodies and immune complexes. Anifrolumab was approved for use in the United States in 2021 and current indications are for treatment of adult patients with active, autoantibody positive systemic lupus erythematosus (SLE) who are receiving standard therapy. Its beneficial effects have not been demonstrated in patients with severe lupus nephritis or central nervous system involvement. Anifrolumab is available under the brand name Saphnelo in single dose vials of 300 mg in 2 mL. The recommended dose is 300 mg given as an intravenous infusion (over 30 minutes) every 4 weeks. Adverse effects include infusion reactions, upper respiratory symptoms and infections, bronchitis, cough, and herpes zoster. Rare but potentially serious side effects include severe hypersensitivity reactions (angioedema or anaphylaxis), severe infections, and possibly malignancies. The potential of reactivation of latent infections such as tuberculosis and hepatitis B from anifrolumab is not clear. Patients receiving anifrolumab should not receive live viral vaccines.

### Hepatotoxicity

In preregistration controlled trials, elevations in serum aminotransferase levels were uncommon (less than 1%) and no more frequent during anifrolumab than with placebo therapy. Elevations in aminotransferase levels above 5 times the ULN were less common on anifrolumab than placebo therapy, and there were no reports of clinically apparent liver injury attributed to anifrolumab. Since its approval and more widescale use, there have been no case reports of liver injury with jaundice linked to anifrolumab therapy. Reactivation of hepatitis B as well as immune-mediated hepatitis can occur with use of immunosuppressive monoclonal antibodies such as infliximab and adalimumab, but instances have not been reported with anifrolumab.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

There is little evidence that anifrolumab is a cause of liver injury, and mechanisms by which it occurs is not clear but might result from immune modulation.

### Outcome and Management

The serum aminotransferase elevations that have been reported during anifrolumab therapy were generally transient, mild and asymptomatic and did not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. There is no evidence of cross sensitivity to hepatic reactions among the various monoclonal antibodies.

Drug Class: Monoclonal Antibodies, Immunosuppressive Agents

Other Drugs for Systemic Lupus Erythematosus: Belimumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Anifrolumab – Saphnelo®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Anifrolumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Anifrolumab | 1326232-46-5 (https://pubchem.ncbi.nlm.nih.gov/substance/249565938) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 September 2023

Abbreviations: PML, progressive multifocal leukoencephalopathy; SLE, systemic lupus erythematosus.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents does not mention anifrolumab).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and toleragens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
FDA: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/761123Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline clinical review of the safety and efficacy of anifrolumab based on results from 1,123 adults treated in 3 controlled trials, stated that the safety results were generally favorable with adverse events reported in 87% of anifrolumab vs 79% of placebo recipients, and serious adverse events in 12% vs 17% including serious infections in 4.8% vs 5.6%, herpes zoster in 12% vs 3%, hypersensitivity reactions in 2.6% vs 0.6%, and ALT elevations above 5 times ULN in 0.3% vs 0.8%).
Furie R, Khamashta M, Merrill JT, Werth VP, Kalunian K, Brohawn P, Illei GG, et al.; CD1013 Study Investigators. Anifrolumab, an anti-interferon-α receptor monoclonal antibody, in moderate-to-severe systemic lupus erythematosus. Arthritis Rheumatol. 2017;69:376-386. (Among 305 adults with SLE treated with anifrolumab [300 or 1000 mg] vs placebo every 4 weeks for 52 weeks, clinical responses occurred in 63% and 54% vs 40%, while adverse event rates were higher with the higher dose including herpes zoster in 5.2% and 9.5% vs 2%; no mention of ALT elevations or hepatotoxicity). 28130918
Morand EF, Furie R, Tanaka Y, Bruce IN, Askanase AD, Richez C, Bae SC, et al.; TULIP-2 Trial Investigators. Trial of anifrolumab in active systemic lupus erythematosus. N Engl J Med. 2020;382:211-221. (Among 362 adults with SLE treated with anifrolumab vs placebo, response rates at 52 weeks was 48% vs 32% and adverse events 88% vs 84%, serious adverse events 8% vs 17%, herpes zoster 7.2% vs 1.1%, serious infections 2.8% vs 5.5%, and infusion reactions 14% vs 8%; no mention of ALT elevations or hepatotoxicity). 31851795
Smith MA, Chiang CC, Zerrouki K, Rahman S, White WI, Streicher K, Rees WA, et al. Using the circulating proteome to assess type I interferon activity in systemic lupus erythematosus. Sci Rep. 2020;10:4462. (Among 1,132 protein measurements from blood samples from patients with SLE, type 1 interferon induced genes were often elevated and patients could be categorized by high vs low levels). 32157125
Anifrolumab (Saphnelo) for systemic lupus erythematosus. Med Lett Drugs Ther. 2021;63(1633):146-147. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of anifrolumab shortly after its approval as therapy of SLE in the US, discusses adverse events of upper respiratory infections, bronchitis, infusion reactions, herpes zoster, and cough, but does not mention ALT elevations or hepatotoxicity). 34550961
Chatham WW, Furie R, Saxena A, Brohawn P, Schwetje E, Abreu G, Tummala R. Long-term safety and efficacy of anifrolumab in adults with systemic lupus erythematosus: results of a phase I open-label extension study. Arthritis Rheumatol. 2021;73:816-825. (Among 218 adult participants with SLE in controlled trials of anifrolumab who were enrolled in an open label extension study, clinical responses were sustained, no new safety signals were observed and there were no liver related serious adverse events). 33225631
Jayne D, Rovin B, Mysler EF, Furie RA, Houssiau FA, Trasieva T, Knagenhjelm J, et al. Phase II randomised trial of type I interferon inhibitor anifrolumab in patients with active lupus nephritis. Ann Rheum Dis. 2022;81:496-506. (Among 147 adults with active lupus nephritis treated with standard therapy and anifrolumab [300 mg every 4 weeks or an intensive early regimen] or placebo, clinical response rates were similar among the three groups while herpes zoster was more frequent with anifrolumab [17% vs 8%]; no mention of ALT elevations or hepatotoxicity). 35144924
Kalunian KC, Furie R, Morand EF, Bruce IN, Manzi S, Tanaka Y, Winthrop K, et al. A randomized, placebo-controlled phase III extension trial of the long-term safety and tolerability of anifrolumab in active systemic lupus erythematosus. Arthritis Rheumatol. 2023;75:253-265. (Among 560 adults with SLE enrolled in a long term extension study of anifrolumab [300 mg every 4 weeks], adverse events occurred in 93% which were scored as serious in 26%, herpes zoster in 13% and severe infections in 10%, 1 case of anaphylaxis, and 12 malignancies; no mention of ALT elevations or hepatoxicity and no cases of active tuberculosis). 36369793
Neupane B, Shukla P, Slim M, Martin A, Petri M, Bertsias GK, Kim AHJ, et al. Belimumab versus anifrolumab in adults with systemic lupus erythematosus: an indirect comparison of clinical response at 52 weeks. Lupus Sci Med. 2023;10:e000907. (Analysis of 5 trials of belimumab and 3 of anifrolumab in adults with moderate-to-severe SLE found similar rates of clinical response to both agents; no analysis of adverse events). 37147022
Kalunian KC, Furie R, Morand EF, Bruce IN, Manzi S, Tanaka Y, Winthrop K, et al. A randomized, placebo-controlled phase III extension trial of the long-term safety and tolerability of anifrolumab in active systemic lupus erythematosus. Arthritis Rheumatol. 2023;75:253-265. (Among 560 adults with SLE enrolled in a long term extension study of anifrolumab [300 mg every 4 weeks], adverse events occurred in 93% which were scored as serious in 26%, herpes zoster in 13% and severe infections in 10%, 1 case of anaphylaxis, and 12 malignancies; no mention of ALT elevations or hepatoxicity and no cases of active tuberculosis). 36369793

## OTHER REFERENCE LINKS

Recent References on Anifrolumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Anifrolumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Anifrolumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Anifrolumab)